# Cidofovir

## OVERVIEW

### Introduction

Cidofovir is a nucleoside analogue and antiviral agent which is used in therapy of serious cytomegalovirus infections in immunocompromised patients. Cidofovir has been associated with mild-to-moderate serum aminotransferase elevations during intravenous therapy, but has not been convincingly linked to cases of clinically apparent acute liver injury.

### Background

Cidofovir (sye dof' oh vir) is an acyclic nucleoside monophosphate and cytosine analogue with potent activity against replication of several herpes viruses, including cytomegalovirus (CMV). Cidofovir is phosphorylated intracellularly and competes with cytosine, resulting in DNA chain termination and inhibition of DNA viral synthesis. Cidofovir has activity in cell culture against several herpes viruses, papilloma, polyoma, pox and adenoviruses. Cidofovir is poorly absorbed orally and must be given intravenously, usually administered with probenecid to inhibit its rapid renal excretion. Cidofovir is indicated for therapy of cytomegalovirus retinitis and off label is used to treat serious adenovirus and acyclovir-resistant herpes simplex infections in immunocompromised individuals. Cidofovir was approved for use in the United States in 1996 and has limited use, largely because of its potential for nephrotoxicity. Cidofovir is available as an intravenous formulation of 75 mg/mL under the brand name of Vistide. The usually recommended dose in adults is 5 mg/kg infused over one hour, once weekly for two weeks, but dose modifications are required if there is renal insufficiency. Probenecid is given concurrently. Side effects include headache, dizziness, confusion, fever, fatigue, abdominal pain, renal dysfunction and rash.

### Hepatotoxicity

Intravenous cidofovir therapy is associated with mild-to-moderate elevations in serum ALT levels in a proportion of patients, but the elevations are usually self-limited and do not require dose modification. Nephrotoxicity is often dose limiting, which may account for the absence of clinically significant cases of liver injury associated with cidofovir therapy. Cases of clinically apparent liver injury have been reported during cidofovir therapy, but the role of this agent has been difficult to define because most patients who receive cidofovir have severe immunodeficiency and are receiving multiple other agents, some of which are known hepatotoxins. Several instances of acute liver failure, lactic acidosis and fatty liver have been described in patients taking cidofovir, but other nucleoside analogues such as zidovudine, stavudine or didanosine were being taken concurrently.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The absence of hepatotoxicity from cidofovir is probably related to the fact that it is rapidly excreted in the urine and binds to the anion transported in the convoluted tubules, leading to its accumulation and renal toxicity.

### Outcome and Management

The minor aminotransferase elevations associated with cidofovir therapy are usually self-limited and do not require dose modification or discontinuation of therapy.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cidofovir – Vistide®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cidofovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cidofovir | 113852-37-2 | C8-H14-N3-O6-P | Cidofovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 October 2017

Núñez M. Herpesviridae treatment. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents mentions that ALT elevations, hepatic necrosis and jaundice were reported in clinical trials using cidofovir ).
Acosta EP, Flexner C. Antiviral agents(nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 20136, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Lea AP, Bryson HM. Cidofovir. Drugs 1996; 52: 225-30. (Review of structure, mechanism of action, pharmacokinetics, efficacy and safety of cidofovir, a cytidine nucleotide analogue shown to be effective in treatment of CMV retinitis; no mention of liver toxicity). 8841740
Studies of Ocular Complications of AIDS Research Group in Collaboration with the AIDS Clinical Trials Group. Parenteral cidofovir for cytomegalovirus retinitis in patients with AIDS: the HPMPC peripheral cytomegalovirus retinitis trial. A randomized, controlled trial. Ann Intern Med 1997; 126: 264-74. (Randomized controlled trial of low vs high dose cidofovir in 64 patients with small peripheral CMV retinitis and AIDS; complications included neutropenia and proteinuria; no mention of hepatotoxicity or ALT elevations). 9036798
Lalezari JP, Stagg RJ, Kuppermann BD, Holland GN, Kramer F, Ives DV, Youle M, et al. Intravenous cidofovir for peripheral cytomegalovirus retinitis in patients with AIDS. A randomized, controlled trial. Ann Intern Med 1997; 126: 257-63. (Controlled trial of 4 weeks of cidofovir in 48 patients with CMV retinitis and HIV infection; neutropenia [15%] and proteinuria [12%] were the most significant adverse events; no mention of hepatotoxicity or ALT elevations). 9036797
Jacobson MA. Treatment of cytomegalovirus retinitis in patients with the acquired immunodeficiency syndrome. N Engl J Med 1997; 337: 105-15. (Review of natural history, outcome and therapy of CMV retinitis focusing on ganciclovir, foscarnet and cidofovir; no mention of hepatotoxicity in discussion of side effects of the 3 drugs). 9211681
Lalezari JP. Cidofovir: a new therapy for cytomegalovirus retinitis. J Acquir Immune Defic Syndr Hum Retrovirol 1997; 14 (Suppl 1): S22-6. (Review of safety and efficacy of cidofovir as therapy of CMV retinitis; no mention of hepatotoxicity). 9058614
Lalezari JP, Holland GN, Kramer F, McKinley GF, Kemper CA, Ives DV, Nelson R, et al. Randomized, controlled study of the safety and efficacy of intravenous cidofovir for the treatment of relapsing cytomegalovirus retinitis in patients with AIDS. J Acquir Immune Defic Syndr Hum Retrovirol 1998; 17: 339-44. (Controlled trial of two doses of intravenous cidofovir every 1-2 weeks for up to 1 year; no mention of hepatotoxicity or ALT elevations). 9525435
Plosker GL, Noble S. Cidofovir: a review of its use in cytomegalovirus retinitis in patients with AIDS. Drugs 1999; 58: 325-45. (Review of efficacy and safety of cidofovir for CMV retinitis in HIV-infected patients; nephrotoxicity is the major dose limiting adverse effect; no mention of hepatotoxicity or ALT elevations during therapy). 10473024
Biron KK. Antiviral drugs for cytomegalovirus diseases. Antiviral Research 2006; 71: 154-63. (Review of CMV infection and the drugs used to treat it, including cidofovir, ganciclovir, foscarnet and acyclovir, does not mention ALT elevations or hepatotoxicity). 16765457
Drugs for non-HIV viral infections. Treat Guidel Med Lett 2007; 5: 59-70. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for cidofovir). 17565338
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents including one due to valacyclovir, but none were attributed to cidofovir). 18955056
Caruso Brown AE, Cohen MN, Tong S, Braverman RS, Rooney JF, Giller R, Levin MJ. Pharmacokinetics and safety of intravenous cidofovir for life-threatening viral infections in pediatric hematopoietic stem cell transplant recipients. Antimicrob Agents Chemother 2015; 59: 3718-25. (Among 12 children with various symptomatic and severe herpes or adenoviral infections after hematopoietic cell transplantation who were treated with a single dose of cidofovir, there were no instances of hepatotoxicity, but two children developed renal dysfunction). 25733509
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases were attributed to antiviral agents, but none to cidofovir). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cidofovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cidofovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cidofovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cidofovir)